# Mirabegron

## OVERVIEW

### Introduction

Mirabegron is a beta-3 adrenergic agonist that is used for treatment of overactive bladder syndrome. Mirabegron has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Mirabegron (mir" a beg' ron) is a synthetic beta-3 adrenergic agonist which binds to receptors in the bladder that causes relaxation of the detrusor smooth muscle and results in an increase in the bladder capacity. Mirabegron has been evaluated as therapy of the overactive bladder syndrome, a condition marked by urgency, frequency, nocturia and incontinence that occurs most commonly in older women. Other therapies of overactive bladder include anticholinergics, but these are only partially effective and can have troublesome side effects, particularly in the elderly. In several short term clinical trials, mirabegron was found to increase voided volume and decrease episodes of incontinence and urinary frequency modestly. Mirabegron was approved for use in the United States in 2012 as treatment of overactive bladder with symptoms of urgency, incontinence, and frequency. In 2021, the indications were expanded to include treatment of children with neurogenic detrusor muscle instability using formulations of mirabegron granules. Mirabegron is available as 25 and 50 mg extended-release tablets under the brand name Myrbetriq. The typical dose in adults is 25 to 50 mg orally once daily. Mirabegron is also available as granules in solution of 8 mg/mL, and the typical dose in children is 48 or 80 mg daily. Side effects are not common, but can include nausea, diarrhea, constipation, dizziness, tachycardia, palpitations, hypertension, and headache. Rare, but potentially severe side effects include hypertension, urinary retention, and hypersensitivity reactions, angioedema, and rash.

### Hepatotoxicity

In preregistration clinical trials, serum aminotransferase elevations were uncommon and mild in patients treated with mirabegron and rates of serum enzyme elevations were similar to those with placebo treatment. Among several thousands of patients treated, there were no episodes of clinically apparent liver injury. Since its approval and more widescale use, there have not been any published reports of hepatotoxicity attributed to mirabegron. However, the product label for mirabegron mentions occasional elevations in ALT and AST associated with treatment as well as a case of Stevens Johnson syndrome with aminotransferase elevations. Thus, mirabegron may cause hepatic injury as a part of a generalized hypersensitivity reactions.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of liver injury due to mirabegron is not known but might result from a generalized hypersensitivity reaction. Mirabegron is metabolized in part by CYP 2D6, but drug-drug interactions with agents that inhibit or induce this enzyme are uncommon.

Drug Class: Urologic Agents, Overactive Bladder Syndrome Agents

Other Drugs in the Subclass, Overactive Bladder Syndrome Agents: Darifenacin, Fesoterodine, Flavoxate, Hyoscyamine, Oxybutynin, Solifenacin, Tolterodine, Trospium, Vibegron

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mirabegron – Myrbetriq®

DRUG CLASS

Urologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mirabegron)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mirabegron | 223673-61-8 | C21-H24-N4-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 14 July 2023

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of mirabegron).
Westfall TC, Macarthur H, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 191-223. (Textbook of pharmacology and therapeutics).
Herschorn S, Barkin J, Castro-Diaz D, Frankel JM, Espuna-Pons M, Gousse AE, Stölzel M, et al. A phase III, randomized, double-blind, parallel-group, placebo-controlled, multicentre study to assess the efficacy and safety of the β_3_adrenoceptor agonist, mirabegron, in patients with symptoms of overactive bladder. Urology 2013; 82: 313-20. (Among 1306 patients with overactive bladder syndrome treated with mirabegron [25 or 50 mg] or placebo daily for 12 weeks, episodes of incontinence and numbers of micturitions per day decreased with mirabegron, and side effects were mild and "the overall incidence of hepatic treatment emergent adverse events was similar across treatment groups; most were mild or moderate"). 23769122
Nitti VW, Khullar V, van Kerrebroeck P, Herschorn S, Cambronero J, Angulo JC, Blauwet MB, et al. Mirabegron for the treatment of overactive bladder: a prespecified pooled efficacy analysis and pooled safety analysis of three randomised, double-blind, placebo-controlled, phase III studies. Int J Clin Pract 2013; 67: 619-32. (In a pooled analysis of 3 placebo controlled trials, 3542 patients with overactive bladder syndrome were treated with mirabegron [25, 50 or 100 mg] or placebo daily for 12 weeks; adverse event rates were no different with mirabegron than placebo; no mention of ALT elevations or hepatotoxicity). 23692526
Khullar V, Amarenco G, Angulo JC, Cambronero J, Høye K, Milsom I, Radziszewski P, et al. Efficacy and tolerability of mirabegron, a β(3)-adrenoceptor agonist, in patients with overactive bladder: results from a randomised European-Australian phase 3 trial. Eur Urol 2013; 63: 283-95. (Among 1978 patients with overactive bladder syndrome treated with once daily mirabegron [50 or 100 mg], tolterodine [4 mg] or placebo for 12 weeks, adverse event rates were similar among groups, and "changes in...serum chemistry parameters...were small and consistent across treatment groups"). 23182126
Chapple CR, Dvorak V, Radziszewski P, Van Kerrebroeck P, Wyndaele JJ, Bosman B, Boerrigter P, et al.; Dragon Investigator Group. A phase II dose-ranging study of mirabegron in patients with overactive bladder. Int Urogynecol J 2013; 24: 1447-58. (Among 928 adults with overactive bladder treated with mirabegron [25, 50, 100 or 200 mg daily], there was a dose related reduction in frequency of micturition, and side effects included increase in pulse rate at the high doses, but "there were no clinically relevant changes in laboratory parameters"). 23471546
Otsuki H, Kosaka T, Nakamura K, Mishima J, Kuwahara Y, Tsukamoto T. β3-Adrenoceptor agonist mirabegron is effective for overactive bladder that is unresponsive to antimuscarinic treatment or is related to benign prostatic hyperplasia in men. Int Urol Nephrol 2013; 45: 53-60. (Among 97 patients with overactive bladder treated with mirabegron [50 mg daily] for 8 weeks, 74% had improvement in symptoms and there was no liver related adverse events). 23212147
Mirabegron (Myrbetriq) for overactive bladder. Med Lett Drugs Ther 2013; 55 (1410): 13-5. (Concise review of mechanism of action, clinical efficacy, safety and costs of mirabegron and other treatments for overactive bladder syndrome; mentions side effects of nausea, diarrhea, constipation, dizziness, tachycardia and headache, but not ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to mirabegron). 23419359
Nitti VW, Chapple CR, Walters C, Blauwet MB, Herschorn S, Milsom I, Auerbach S, et al. Safety and tolerability of the β3 -adrenoceptor agonist mirabegron, for the treatment of overactive bladder: results of a prospective pooled analysis of three 12-week randomised Phase III trials and of a 1-year randomised Phase III trial. Int J Clin Pract 2014; 68: 972-85. (Pooled analysis of safety of mirabegron [25, 50 and 100 mg daily] from three 12-week and one 1-year studies reported side effects of hypertension, headache, back pain, drug mouth and constipation low and similar to rates in placebo recipients; elevations in ALT above 3 times ULN occurred in 1.5% on mirabegron, 1.4% on placebo and 2.0% on tolterodine, and no patient had concurrent elevation in bilirubin or clinically apparent liver injury). 24703195
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to mirabegron). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and Outcomes of 899 Patients With Drug-Induced Liver Injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to mirabegron or other agents for overactive bladder syndrome). 25754159
Batista JE, Kölbl H, Herschorn S, Rechberger T, Cambronero J, Halaska M, Coppell A, et al.; BEYOND study group. The efficacy and safety of mirabegron compared with solifenacin in overactive bladder patients dissatisfied with previous antimuscarinic treatment due to lack of efficacy: results of a noninferiority, randomized, phase IIIb trial. Ther Adv Urol 2015; 7: 167-79. (Among 1887 patients with overactive bladder treated with mirabegron or solifenacin for 12 weeks, decreases in micturition rates were similar with the two drugs [3.0 and 3.1 per day] as were rates of adverse events; no mention of ALT levels or hepatotoxicity). 26445596
Thiagamoorthy G, Cardozo L, Srikrishna S. Drug therapy for an overactive bladder. Womens Health (Lond) 2015; 11: 445-8. (Overactive bladder is defined as urinary urgency, usually with frequency and nocturia with or without incontinence in the absence of infection or other known cause; medical therapy being use of anticholinergics or beta-3 agonists such as mirabegron which has fewer side effects than typical anticholinergics). 26238677
Warren K, Burden H, Abrams P. Mirabegron in overactive bladder patients: efficacy review and update on drug safety. Ther Adv Drug Saf 2016; 7: 204-216. (Review of the 3 phase III trials of mirabegron for overactive bladder syndrome; no discussion of liver related adverse events). 27695622
Kallner HK, Christensson AA, Elmér C, Flam B, Altman D. Safety and efficacy of mirabegron in daily clinical practice: a prospective observational study. Eur J Obstet Gynecol Reprod Biol 2016; 203: 167-72. (Among 221 women with overactive bladder syndrome treated in clinical practice at a single medical center, 16 patients stopped therapy because of side effects including palpitations, chest pain, dry mouth, diarrhea, headache, fatigue, blurred vision and edema; no mention of liver related adverse events). 27318184
Blais AS, Nadeau G, Moore K, Genois L, Bolduc S. Prospective pilot study of mirabegron in pediatric patients with overactive bladder. Eur Urol 2016; 70: 9-13. (Among 58 children with overactive bladder treated with mirabegron for a median of 11 months, bladder capacity increased and incontinence decreased, while most children tolerated therapy with no change in pulse or blood pressure and infrequent symptoms of nausea, personality change and nasal stuffiness; no mention of ALT elevations or hepatotoxicity). 26876327
Sager C, Sanmartino M, Burek C, Gomez YR, Vazquez Patiño M, Weller S, Ruiz J, et al. Efficacy and safety of Mirabegron as adjuvant treatment in children with refractory neurogenic bladder dysfunction. J Pediatr Urol. 2020;16:655.e1-655.e6. (Among 37 children with neurogenic bladder dysfunction treated with mirabegron [25 mg daily], bladder capacity increased, while therapy was well tolerated, and ALT and AST values did not change).
Baka-Ostrowska M, Bolong DT, Persu C, Tøndel C, Steup A, Lademacher C, Martin N. Efficacy and safety of mirabegron in children and adolescents with neurogenic detrusor overactivity: An open-label, phase 3, dose-titration study. Neurourol Urodyn. 2021;40:1490-1499. (Among 86 children ages 3 to 18 years treated with mirabegron [25 to 50 mg daily] for up to 24 weeks, bladder capacity was increased, while adverse events arose in 59% of patients but few were considered related with therapy; no mention of ALT elevations but one patient had transient, mild creatine kinase and AST elevations). 34058027
Soliman MG, El-Abd S, El-Gamal OM, Raheem AA, Abou-Ramadan AR, El-Abd AS. Mirabegron versus solifenacin in children with overactive bladder: prospective randomized single-blind controlled trial. Urol Int. 2021;105:1011-1017. (Among 190 children ages 5 to 14 years with overactive bladder syndrome treated with mirabegron [50 mg], solifenacin [5 mg], or placebo once daily for 3 months, clinical responses were higher with medical therapy [88% and 90% vs 56%], while adverse events included dry mouth [3% and 10% vs 0%], constipation [3% and 11% vs 1%]; no mention of ALT elevations or hepatotoxicity). 34010843
Kinjo M, Masuda K, Nakamura Y, Miyakawa J, Tambo M, Fukuhara H. Comparison of mirabegron and vibegron in women with treatment-naive overactive bladder: A randomized controlled study. Urology. 2023;175:67-73. (Among 199 adult women with overactive bladder syndrome treated with 50 mg of either mirabegron or vibegron daily for 12 weeks, response rates were similar in both groups as were overall rates of adverse events [17.5% vs 15.7%], discontinuations [6.2% vs 6.8%], constipation [10.3% vs 11.8%], dry mouth [both 1%], and rash [2% vs 1%]; no mention of ALT elevations or hepatotoxicity). 36822245
Drugs for overactive bladder. Med Lett Drugs Ther. 2023;65:41-45. (Concise review of drugs approved for therapy of overactive bladder in the US including anticholinergic agents [darifenacin, fesoterodine, oxbutynin, solifenacin, tolterodine and trospium] and beta-3 adrenergic receptor agonists [mirabegron and vibegron] including clinical efficacy, safety, and costs; no mention of ALT elevations or hepatotoxicity of any of the agent discussed). 36897601

## OTHER REFERENCE LINKS

1 Recent References on Mirabegron: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mirabegron+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Mirabegron: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mirabegron)